# Cisplatin

## OVERVIEW

### Introduction

Cisplatin is the prototype platinum coordination complex classified as an alkylating agent and used intravenously in the treatment of several forms of cancer. Cisplatin has been associated with a low rate of serum enzyme elevations and with rare cases of clinically apparent, acute liver injury.

### Background

Cisplatin (sis pla' tin) was the first chemotherapeutic agent of its subclass to be discovered. It is an inorganic, water soluble complex containing a central platinum atom surrounded by 2 chlorine atoms and ammonia moieties in the cis position in the horizontal plane. Cisplatin forms irreversible covalent links with DNA, causing cross linking of DNA chains as well as breaks in the DNA chain and missense mutations. The DNA injury triggers cell death and inhibits RNA and protein synthesis, particularly in rapidly dividing cells. Cisplatin has activity against multiple tumor types and was approved for use by the United States in 1978. Current indications include testicular, ovarian and bladder cancer. It is also used in combination with other agents in head and neck, breast, lung and colon cancer. Cisplatin is administered parenterally and is available in 50 and 100 mg vials in generic forms and under the brand name Platinol. The recommended dose varies by indication, tumor type, patient age and body weight. Common side effects include nausea, vomiting, bone marrow suppression, electrolyte imbalance, neuropathy, ototoxicity and nephrotoxicity. Cisplatin is mutagenic, teratogenic and carcinogenic and its use has been show to increase the risk of secondary malignancies, particularly leukemia.

### Hepatotoxicity

The platinum compounds generally are not considered to be hepatotoxic, but cisplatin has been associated with a low rate of serum enzyme elevations during therapy. These elevations are usually mild, self-limited and asymptomatic, rarely requiring dose modification. There have been only rare case reports of clinically apparent liver injury attributed to cisplatin. In one instance, steatosis and necrosis (steatohepatitis) was found by liver biopsy in a patient who developed liver enzyme elevations 4 weeks after starting a regimen of cisplatin. In another instance, hepatocellular liver injury was described. The number of cases of liver injury attributed to cisplatin have been too few to characterize the liver injury clinically. Autoimmune and immunoallergic features have not been described and cases have all been self-limited. Cisplatin is usually given in combination with other antineoplastic agents and adverse events that occur with these combinations cannot always be attributed to cisplatin. In this regard, individual case reports of reactivation of hepatitis B, sinusoidal obstruction syndrome and severe hyperammonemic coma (without liver injury) have been described after chemotherapeutic regimens that include cisplatin and other platinum coordination complexes such as carboplatin and oxaliplatin.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatotoxicity from cisplatin is not known. There have been extremely few cases of cisplatin induced hepatotoxicity described and generally, the platinum coordination complexes have not been considered to be hepatotoxic. Recently however, oxaliplatin when given in multiple courses has been linked to development of nodular regenerative hyperplasia and non-cirrhotic portal hypertension.

### Outcome and Management

Liver injury from cisplatin is rare and when it does occur, the severity in published cases was generally mild and the outcome benign. There is likely to be cross sensitivity to liver toxicities of the various platinum coordination complexes and rechallenge should be avoided.

Drug Class: Antineoplastic Agents, Alkylating Agents

Other Drugs in the Subclass, Platinum Coordination Complexes: Carboplatin, Oxaliplatin

## CASE REPORT

### Case 1. 47 year old man with acute liver toxicity following cisplatin therapy.(1)

A 47 year old man with bladder carcinoma developed jaundice 4 weeks after a single infusion of cisplatin given as adjuvant chemotherapy. The patient had no history of liver disease, alcohol abuse, risk factors for viral hepatitis or previous drug allergies. On examination, he was jaundiced, but without fever, rash or lymphadenopathy. The serum bilirubin was minimally elevated at 2.2 mg/dL and AST 58 U/L with alkaline phosphatase twice the upper limit of the normal range. Tests for hepatitis B were normal as was imaging of the gall bladder. His serum bilirubin returned to normal and he received another dose of cisplatin but developed similar abnormalities, detected one month later. After the fifth course of cisplatin, serum bilirubin levels rose to 9.8 mg/mL, AST 144 U/L and alkaline phosphatase twice normal. A liver biopsy showed steatosis, hepatocellular ballooning necrosis and mild cholestasis. The liver test abnormalities quickly resolved and he remained asymptomatic and without evidence of recurrent carcinoma 6 months later.

#### Key Points

Medication: | Cisplatin
Pattern: | Cholestatic (R=~1.0)
Severity: | 2+ (jaundice, not requiring hospitalization)
Latency: | 2-4 weeks
Recovery: | 4 weeks
Other medications: | Furosemide 40-80 mg intravenously with each infusion of cisplatin

#### Comment

A distinctly unusual form of drug induced liver injury marked by recurrent cholestasis without symptoms or severe injury, possibly due to an idiosyncrasy of cisplatin metabolism leading to cholestatic injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cisplatin – Generic, Platinol®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cisplatin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cisplatin | 15663-27-1 | C12-H6-N2-Pt

## CITED REFERENCE

1 Cavalli F, Tschopp L, Sonntag RW, Zimmermann A. (1978). A case of liver toxicity following cis-dichlorodiammineplatinum (II) treatment. Cancer Treat Rep.

## ANNOTATED BIBLIOGRAPHY

References updated: 12 September 2020

Abbreviations: BMI, body mass index; CT, computerized tomography; NRH, nodular regenerative hyperplasia; SOS, sinusoidal obstruction syndrome; HVPG, hepatic venous pressure gradient; SAMe, S-adenosylmethionine.
Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that cisplatin had been reported to cause dose related serum enzyme elevations and has been linked to steatosis and necrosis, whereas carboplatin has been linked to rare instances of cholestatic and hepatocellular injury).
DeLeve LD. Liver sinusoidal endothelial cells and liver injury. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 139-43. (Review of liver injury to sinusoidal endothelial cells caused by medications mentions that oxaliplatin as capable of causing sinusoidal dilatation, peliosis hepatis, nodular regenerative hyperplasia and sinusoidal obstruction syndrome).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-201. (Textbook of pharmacology and therapeutics).
Peyrone M. Ueber die einwirkung des ammoniaks auf platinchlorür. der Chemie und Pharmacie 1844; 51: 1-29. (Initial description of cisplatin).
Lippman AJ, Helson C, Helson L, Krakoff IH. (1973). Clinical trials of cis-diamminedichloroplatinum (NSC-119875). Cancer Chemother Rep. (Pilot study of cisplatin in 26 patients with advanced malignancies; 1 [4%] patient on high doses had transient mild elevations in AST with resolution in 5 days).
Hill JM, Loeb E, MacLellan A, Hill NO, Khan A, King JJ. (1975). Clinical studies of platinum coordination compounds in the treatment of various malignant diseases. Cancer Chemother Rep. (Among 78 patients with cancer treated with cisplatin, side effects included nausea, vomiting, diarrhea, tinnitus, hearing loss, bone marrow suppression, nephropathy, and minor elevations of AST [peak value 81 U/L]).
Hayes DM, Cvitkovic E, Golbey RB, Scheiner E, Helson L, Krakoff IH. (1977). High dose cis-platinum diammine dichloride. Cancer. (Among 60 patients treated with escalating doses of cisplatin, 2 had transient AST elevations without jaundice or change in Alk P levels).
Jacobs C, Bertino JR, Fogginet DR, Fee WE, Goode RL. (1978). 24-hour infusion of cis-platinum in head and neck cancers. Cancer. (Among 18 patients given 34 courses of cisplatin for advanced head and neck cancers, 2 had transient AST elevations; no details provided on symptoms or jaundice).
Cavalli F, Tschopp L, Sonntag RW, Zimmermann A. (1978). A case of liver toxicity following cis-dichlorodiammineplatinum(II) treatment. Cancer Treat Rep. (47 year old man developed jaundice 4 weeks after an initial cycle of cisplatin [bilirubin 2.2 mg/dL, AST 58 U/L, Alk P 55 U/L], values falling to normal 4 weeks later, and similar elevations occurring with subsequent cycles until a peak bilirubin 9.8 mg/dL after fifth course [AST 144 U/L, biopsy showing fatty change, focal necrosis and cholestasis]: cisplatin Case 1).
Canetta R, Franks C, Smaldone L, Bragman K, Rozencweig M. (1987). Clinical status of carboplatin. Oncology (Williston Park). (Summary of clinical studies of carboplatin, a cisplatin derivative; carboplatin and cisplatin have similar efficacy against ovarian, cervical, and small cell lung cancer, but carboplatin is better tolerated; ALT elevations in 16% of patients, bilirubin in 4%, no mention of clinically apparent hepatotoxicity).
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. (1987). Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation. (Among 235 patients undergoing bone marrow transplantation between 1982 and 1985, SOS developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population).
Tran A, Housset C, Boboc B, Tourani J-M, Carnot F, Berthelot P. (1991). Etoposide (VP 16-213) induced hepatitis: report of three cases following standard dose treatments. J Hepatol. (3 patients, ages 52 to 73 years, developed jaundice 1-5 months after starting etoposide with several other cyclic antineoplastic agents including cisplatin and cyclophosphamide in two [bilirubin 4.2-13.0 mg/dL, ALT 790-2270 U/L, Alk P 181-280 U/L], resolving in 4-10 weeks and no recurrence on a similar regimen without etoposide in one patient).
Washington K, Lane KL, Meyers WC. (1993). Nodular regenerative hyperplasia in partial hepatectomy specimens. Am J Surg Pathol. (Pathological review of liver resections from 72 patients showed nodular regenerative hyperplasia in 5, all of whom had colon cancer metastases and had been treated with chemotherapy: usually 5-fluorouracil; 9 patients had hyperplastic foci some of whom had received cisplatin and other agents including cyclophosphamide, VP-16 and carmustine).
Cersosimo RJ. (1993). Hepatotoxicity associated with cisplatin chemotherapy. Ann Pharmacother. (69 year old man developed liver enzyme elevations during second day of each cycle of cisplatin therapy).
Hartmann JT, Lipp H-P. (2003). Toxicity of platinum compounds. Expert Opin Pharmacother. (Review of pharmacology, mechanism of action, adverse effects and tolerance of platinum containing alkylating agents; "Mild reversible increases in liver function tests can occur in patients who have received platinum compounds. However, the platinum compounds are generally not classified as hepatotoxic drugs").
Rubbia-Brandt L, Audard V, Sartoretti P, Roth AD, Brezault C, Le Charpentier M, Dousset B, et al. (2004). Severe hepatic sinusoidal obstruction associated with oxaliplatin-based chemotherapy in patients with metastatic colorectal cancer. Ann Oncol. (Among 153 patients undergoing hepatic resection for colon cancer, centrolobular congestion and necrosis was found in nontumor liver tissue in 51% of those who received neoadjuvant chemotherapy, but in none undergoing surgery alone; oxaliplatin as the most frequently implicated agent; follow up biopsies often showed fibrosis).
Lu Y, Cederbaum AI. (2006). Cisplatin-induced hepatotoxicity is enhanced by elevated expression of cytochrome P450 2E1. Toxicol Sci. (Prooxidants and stimulation of CYP 2E1 enhanced while glutathione repletion decreased injury to hepatocytes by cisplatin in vitro).
Higashiyama H, Harabayashi T, Shinohara N, Chuma M, Hige S, Nonomura K. (2007). Reactivation of hepatitis in a bladder cancer patient receiving chemotherapy. Int Urol Nephrol. (A 59 year old woman with bladder cancer who was an HBV carrier developed severe reactivation of hepatitis B after 2 cycles of chemotherapy with methotrexate, epiadriamycin and cisplatin, resolving with lamivudine and prednisolone therapy).
Zorzi D, Laurent A, Pawlik TM, Lauwers GY, Vauthey J-N, Abdalla EK. (2007). Chemotherapy-associated hepatotoxicity and surgery for colorectal liver metastases. Brit J Surg. (Systematic review of liver toxicity occurring after preoperative systemic chemotherapy for colorectal liver metastases, oxaliplatin has been linked to histological changes in microvasculature of the liver but not with increased mortality rate or hepatic failure).
Liao Y, Lu X, Lu C, Li G, Jin Y, Tang H. (2008). Selection of agents for prevention of cisplatin-induced hepatotoxicity. Pharmacol Res. (Analysis of factors that decreased hepatotoxicity of cisplatin in animal model found antioxidants and glutathione precursors were effective in decreasing ALT elevations during therapy).
McDonald GB. (2010). Hepatobiliary complications of hematopoietic cell transplantation, 40 years on. Hepatology. (Review of liver complications of bone marrow [hematopoietic cell] transplantation, which have become less frequent with better understanding of their causes and means of prevention; the rate of SOS has decreased because of avoidance of more aggressive ablative therapies [total body irradiation and high doses of cyclophosphamide] and better understanding of pharmacokinetics of the alkylating agents).
Hajj A, Ghosn M, Mourad D, Hojaiban K, Mousallem P, Khabbaz LR. (2017). Lethal hepatotoxicity following 5-fluorouracil/cisplatin chemotherapy: a relevant case report. Per Med. (72 year old woman with metastatic esophageal carcinoma developed pain and jaundice 11 days after starting chemotherapy with cisplatin [120 mg iv day 1] and 5-fluorouracil [1500 mg iv days 1 to 4], with progressive multiorgan failure and death 3 days later [bilirubin 25.3 mg/dL, ALT 126 U/L, Alk P 51 U/L, GGT 106 U/L], INR, ammonia levels and hepatic histology not provided).
Quintanilha JCF, de Sousa VM, Visacri MB, Amaral LS, Santos RMM, Zambrano T, Salazar LA, et al. (2017). Involvement of cytochrome P450 in cisplatin treatment: implications for toxicity. Cancer Chemother Pharmacol. (Review of the possible role of the cytochrome P450 system in cisplatin renal and hepatic toxicity despite the fact that it is not metabolized by CYP enzymes, injury is usually attribute to formation of reactive oxidative species from mitochondrial damage).

## OTHER REFERENCE LINKS

1 Recent References on Cisplatin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cisplatin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Cisplatin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cisplatin)